# Tedizolid

## OVERVIEW

### Introduction

Tedizolid is an oxazolidinone antibiotic, similar to linezolid, which has a broad spectrum of activity against gram positive bacteria including methicillin resistant Staphyloccocal aureus (MRSA). Tedizolid has been associated with a low rate of transient serum aminotransferase elevations during therapy, but has not been linked to instances of clinically apparent acute liver injury.

### Background

Tedizolid (te diz' oh lid) is a synthetic, second generation oxazolidinone antibiotic, similar to linezolid, that has broad bactericidal activity against gram positive organisms such as enterococci and staphylococci and most streptococci. Importantly, tedizolid has potent activity against Methicillin resistant strains of Staphyloccocus aureus (MRSA). Tedizolid acts by binding to the 50S subunit of bacterial ribosome, preventing the formation of the functional ribosomal 70S subunit and thereby blocking bacterial protein synthesis. In several randomized controlled trials, tedizolid was found to be similar in efficacy (“non-inferior”) to linezolid as therapy of acute bacterial skin and skin-structure infections. Tedizolid was approved for use in the United States in 2014 and is currently indicated for treatment of skin and skin structure infections caused by susceptible bacteria, including Staphylococcus aureus. Because of its activity against multidrug resistant enterococci and staphylococci, the use of tedizolid is usually reserved for severe infections where methicillin or penicillin resistance is found. Tedizolid is available in tablets of 200 mg under the name Sivextro. It is also available as a powder in single dose vials for reconstitution in solution for intravenous administration. Tedizolid is typically given as a 6 day course of 200 mg once daily, either orally or intravenously. Common minor side effects include nausea, diarrhea, abdominal upset, headache and arthralgias. Rare, but severe side effects that can occur with more prolonged therapy include serotonin syndrome, thrombocytopenia and optic and peripheral neuropathy.

### Hepatotoxicity

Therapy with tedizolid has been associated with mild and transient elevations in serum aminotransferase and alkaline phosphatase levels in 1% to 4% of patients, although similar rates of elevations occur in patients with infections treated with comparable agents including linezolid. In all instances, the elevations occurred without symptoms or jaundice and resolved with discontinuation of the drug.

While tedizolid has not been linked to cases of clinically apparent liver disease with jaundice, linezolid, a similar oxazolidinone antibiotic, has been linked to cases of lactic acidosis and systemic injury. This syndrome generally arises after 1 to 8 weeks of therapy and is sometimes associated with evidence of liver injury and jaundice. Lactic acidosis is usually due to dysfunction or loss of hepatic mitochondria, with resulting microvesicular steatosis and disturbed hepatic function (not necessarily accompanied by jaundice or even ALT or alkaline phosphatase elevations). Other serious side effects associated with mitochondrial damage include peripheral and optic neuropathy, pancreatitis, serotonin syndrome and renal injury. The mitochondrial injury is believed to be due to the inhibition of mitochondrial ribosomal function that matches the known effect of the oxazolidinones on bacterial ribosomal function. Lactic acidosis occurs after 1 to 8 weeks of treatment and can be severe, although it resolves rapidly with discontinuation. In contrast, the optic and peripheral neuropathy due to this class of antibiotics resolves more slowly and can be permanent. Lactic acidosis can be fatal, and hepatic dysfunction and jaundice have been mentioned in severe cases attributed to linezolid. This syndrome has yet to be clearly linked to tedizolid therapy.

Likelihood score: E* (unproven but suspected cause of liver injury).

### Mechanism of Injury

The etiology of serum enzyme elevations during tedizolid therapy is not known and may relate more to the underlying condition rather than injury from tedizolid. Lactic acidosis and peripheral neuropathy from oxazolidinones are probably due to inhibition of mitochondrial ribosomal function and protein synthesis. Indeed, several mitochondrial DNA polymorphisms [2706A>G and 3010G>A] have been identified in patients who developed lactic acidosis while on linezolid that may have represented a genetic predisposition to this adverse event.

### Outcome and Management

The serum aminotransferase and alkaline phosphatase elevations that occur during tedizolid therapy are self-limited and resolve once therapy is stopped. There are no reports of cross sensitization and hepatic injury from tedizolid in persons with hepatic injury from other antibiotics or sulfonamides. The lactic acidosis due to linezolid has been linked to injury to hepatic mitochondria and with microvesicular steatosis, but is usually rapidly reversed with withdrawal of therapy. Treatment with carnitidine, antioxidants, thiamine and prednisone has been used, but has not been shown to be effective. Use of intravenous 20% glucose infusions, which are effective in treating the lactic acidosis of acute fatty liver of pregnancy, Reye syndrome and fialuridine therapy, has not been studied. However, tedizolid has not been definitely linked to this syndrome.

Drug Class: Antiinfective Agents, Miscellaneous, Oxazolidinones

Other Drugs in the Subclass, Oxazolidinones: Linezolid

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tedizolid – Sivextro®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tedizolid)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tedizolid | 856866-72-3 | C17-H15-F-N6-O3 | Tedizolid structure
Linezolid | 165800-03-3 | C16-H20-F-N3-O4 | Linezolid structure

## ANNOTATED BIBLIOGRAPHY

References updated: 2 April 2016

Zimmerman HJ. Zimmerman HJ. Hepatic injury from the treatment of infectious and parasitic diseases. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. pp 589-637. (Expert review of hepatotoxicity published in 1999, before the availability of linezolid and tedizolid which are not mentioned).
Moseley RH. Antibacterial and Antifungal Agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd Edition. Amsterdam: Elsevier, 2013. p. 463-81. (Review of hepatotoxicity of antibiotics; linezolid and tedizolid are not discussed).
MacDougall C, Chambers HF. Oxazolidinones (Linezolid). Protein synthesis inhibitors; miscellaneous antibacterial agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1537-8. (Textbook of pharmacology and therapeutics).
Rubinstein E, Cammarata S, Oliphant T, Wunderink R; Linezolid Nosocomial Pneumonia Study Group. Linezolid (PNU-100766) versus vancomycin in the treatment of hospitalized patients with nosocomial pneumonia: a randomized, double-blind, multicenter study. Clin Infect Dis 2001; 32: 402-12. (396 patients treated with either linezolid or vancomycin at 90 sites had similar rates of clinical response and side effects; liver tests were abnormal in 1.0% of linezolid vs 1.6% of vancomycin treated patients). 11170948
Apodaca AA, Rakita RM. Linezolid-induced lactic acidosis. N Engl J Med 2003; 348: 86-7. (52 year old woman developed intractable nausea and vomiting 11 weeks after starting linezolid and was found to have lactic acidosis [9.9 μmol/L] which was reversed after stopping drug; no mention of hepatic abnormalities). 12510056
Bernard L, Stern R, Lew D, Hoffmeyer P. Serotonin syndrome after concomitant treatment with linezolid and citalopram. Clin Infect Dis 2003; 36: 1197. (81 year old man developed severe lactic acidosis, thrombocytopenia and serotonin syndrome 3 weeks after starting linezolid while also taking citalopram [ALT 66 U/L, CPK 766 U/L, lactate 17.5 μmol/L, pH 6.9], leading to cardiac arrest and hepatic failure, but no information on liver function or histology were given). 12715317
French G. Safety and tolerability of linezolid. J Antimicrob Chemother 2003; 51 (Suppl 2): ii45-53. (Review of adverse events reported in clinical trials of linezolid reported similar rates of adverse events to comparative drugs; diarrhea, nausea and headache in 1-5%: abnormal "liver tests" in 1.0% vs 0.3% of controls. In one study ALT elevations occurred in 2.5% with low- and 9.8% with high-dose linezolid, all elevations were mild and reversible, and similar in rate to comparative agents; overall ALT >2 times ULN occurred in 7.4% vs 7.2%; list of serious adverse events includes "hepatitis"). 12730142
Rubinstein E, Isturiz R, Standiford HC, Smith LG, Oliphant TH, Cammarata S, Hafkin B, et al. Worldwide assessment of linezolid's clinical safety and tolerability: comparator-controlled phase III studies. Antimicrob Agents Chemother 2003; 47: 1824-31. (Safety assessment in 2046 patients who received linezolid vs 2001 on comparator drugs found similar rates of diarrhea [4.3 vs 3.2%], nausea [3.4 vs 2.3%], headache [2.2 vs 1.3%], liver test abnormalities [1.0 vs 0.3%], serious adverse events [11.4 vs 10.6%], and deaths [4.8 vs 4.9%]; two patients on oxacillin-dicloxacillin developed "hepatitis", but no cases described for linezolid cohort). 12760854
Kopterides P, Papadomichelakis E, Armaganidis A. Linezolid use associated with lactic acidosis. Scand J Infect Dis 2005; 37: 153-4. (Elderly man with severe methicillin-resistant staphylococcus aureus infection developed rising lactate [2.0→12.5 μmol/L] over 7 days of linezolid therapy, resolved with discontinuation, no evidence of liver injury). 15764207
Soriano A, Miró O, Mensa J. Mitochondrial toxicity associated with linezolid. N Engl J Med 2005; 353: 2305-6. (Three patients with asthenia and lactic acidosis after 1.5-3 months of linezolid therapy were studied for mitochondrial function in peripheral blood mononuclear cells; complex IV enzymatic activity was decreased). 16306535
De Vriese AS, Coster RV, Smet J, Seneca S, Lovering A, Van Haute LL, et al. Linezolid-induced inhibition of mitochondrial protein synthesis. Clin Infect Dis 2006; 42: 1111-7. (Patient treated with linezolid and rifampicin for 4 months developed loss of vision and lactic acidosis [24.5 μmol/L], renal failure and flaccid paralysis; muscle, liver, kidney and white cells were studied; liver showed micro- and macro-vesicular steatosis, decreased activity and protein of respiratory chain complexes I and IV in mitochondria, but normal mtDNA and morphology by electron microscopy). 16575728
Jaksic B, Martinelli G, Perez-Oteyza J, Hartman CS, Leonard LB, Tack KJ. Efficacy and safety of linezolid compared with vancomycin in a randomized, double-blind study of febrile neutropenic patients with cancer. Clin Infect Dis 2006; 42: 597-607. (Controlled trial of linezolid vs vancomycin for an average of 11 days in 453 patients with cancer and febrile neutropenia found similar safety and efficacy; "the distribution of biochemical test results, including mean values, changes from baseline values and abnormal values, was similar between groups"). 16447103
McKee EE, Ferguson M, Bentley AT, Marks TA. Inhibition of mammalian mitochondrial protein synthesis by oxazolidinones. Antimicrob Agents Chemother 2006; 50: 2042-9. (Like chloramphenicol and tetracycline, the oxazolidinones bind to bacterial as well as mitochondrial ribosomes and inhibit protein synthesis, the binding site being conserved between mitochondrial and gram-positive bacteria). 16723564
Pea F, Scudeller L, Lugano M, Baccarani U, Pavan F, Tavio M, et al. Hyperlactacidemia potentially due to linezolid overexposure in a liver transplant recipient. Clin Infect Dis 2006; 42: 434-5. (59 year old liver transplant recipient developed increased lactate levels after 11 days of linezolid therapy, returning to normal with discontinuation; no mention of other liver tests). 16392096
Narita M, Tsuji BT, Yu VL. Linezolid-associated peripheral and optic neuropathy, lactic acidosis, and serotonin syndrome. Pharmacotherapy 2007; 27: 1189-97. (Review and summary of published literature on severe side effects of linezolid). 17655517
Wiener M, Guo Y, Patel G, Fries BC. Lactic acidosis after treatment with linezolid. Infection. 2007; 35: 278-81. (80 year old woman presented with shortness of breath and lactic acidosis after 19 days of linezolid [pH 7.0, lactate 19 μmol/L], with rapid recovery upon switching to daptomycin). 17646908
Metzxas EI, Falagas ME. Update on the safety of linezolid. Expt Opin Drug Saf 2009; 8: 485-91. (Summary of pooled results of clinical trials of linezolid in 2046 patients; severe side effects occurred in 0.4% including cytopenia, neurological side effects and lactic acidosis; ALT elevations also occurred, and "some patients had to discontinue treatment because of these abnormalities"). 19538105
Savard S, Desmeules S, Riopel J, Agharazii M. Linezolid-associated acute interstitial nephritis and drug rash with eosinophilia and systemic symptoms(DRESS) syndrome. Am J Kidney Dis 2009; 54: e17-20. (84 year old woman developed pruritus, rash, facial edema and eosinophilia on the 7th day of linezolid therapy with interstitial nephritis and mild hepatitis [AST ~90 U/L, GGT ~105 U/L], with rapid response to prednisone after stopping linezolid). 19733945
De Bus L, Depuydt P, Libbrecht L, Vandekerckhove L, Nollet J, Benoit D, Vogelaers D, Van Vlierberghe H. Severe drug-induced liver injury associated with prolonged use of linezolid. J Med Toxicol 2010; 6: 322-6. (55 year old woman developed jaundice and lactic acidosis after 50 days of linezolid and meropenem therapy [bilirubin 12.1 mg/dL, ALT 113 U/L, Alk P 2486 U/L, pH 7.27, lactate 121 mg/dL], with signs of liver failure, but resolving spontaneously over next 3 months). 20358416
Carson J, Cerda J, Chae JH, Hirano M, Maggiore P. Severe lactic acidosis associated with linezolid use in a patient with the mitochondrial DNA A2706G polymorphism. Pharmacotherapy 2007; 27: 771-4. (35 year old woman developed severe lactic acidosis 35 days after starting linezolid; had mitochondrial DNA polymorphism that may have predisposed her to injury). 17461714
Scotton P, Fuser R, Torresan S, Carniato A, Giobbia M, Rossi C, Inojosa WO, Vaglia A. Early linezolid-associated lactic acidosis in a patient treated for tuberculous spondylodiscitis. Infection 2008; 36: 387-8. (81 year old woman developed acidosis 12 days after starting intravenous linezolid [pH 7.24, lactate 18.6 mmol/L], isoniazid, rifampin and ethambutol for atypical tuberculosis, recovering within a week of stopping and later tolerating isoniazid, pyrazinamide and rifampin). 18642110
Lee YR, Powell N, Bonatti H, Sawyer RG, Barroso L, Pruett TL, Sifri CD, Volles D. Early development of lactic acidosis with short term linezolid treatment in a renal recipient. J Chemother 2008; 20: 766-7. (56 year old woman with urosepsis and renal transplant developed metabolic acidosis which worsened with linezolid therapy, but resolved once it was stopped). 19129081
Boutoille D, Grossi O, Depatureaux A, Tattevin P. Fatal lactic acidosis after prolonged linezolid exposure for treatment of multidrug-resistant tuberculosis. Eur J Intern Med 2009; 20: e134-5. (48 year old man developed lactic acidosis 3 months after starting oral linezolid for resistant tuberculosis [pH 7.32, lactate 11.6 mmol/L], while linezolid was stopped, he was found dead 3 weeks later). 19782904
Fernández de Orueta L, Díaz V, Ramírez M, Alvarez R. [Linezolid-induced lactic acidosis]. Enferm Infecc Microbiol Clin 2009; 27: 550-1. (72 year old woman developed lactic acidosis beginning 34 days after starting linezolid with severe distress by day 39 [pH 6.93, lactate 6.1 mmol/L], resolving rapidly upon stopping). 19819595
Velez JC, Janech MG. A case of lactic acidosis induced by linezolid. Nat Rev Nephrol 2010; 6: 236-42. (36 year old man with end stage renal disease on dialysis developed lactic acidosis 6 weeks after starting oral linezolid for vancomycin resistant Enterococcus fecalis [pH 7.31, lactate 12.5 mmol/L, ALT 89 U/L], resolving within a week of stopping; ribosomal DNA polymorphism 2706A>G found, similar to two cases in the literature). 20348931
De Bus L, Depuydt P, Libbrecht L, Vandekerckhove L, Nollet J, Benoit D, Vogelaers D, et al. Severe drug-induced liver injury associated with prolonged use of linezolid. J Med Toxicol 2010; 6: 322-6. (55 year old woman developed jaundice and itching 6-7 weeks after starting linezolid and meropenem [bilirubin 12.1 mg/dL, ALT 113 U/L, Alk P 2,486 U/L, pH 7.27, lactate 121 mg/dL], with biopsy showing microvesicular steatosis and slowly resolving after stopping antibiotics, the patient later dying of septic shock). 20358416
Cope TE, McFarland R, Schaefer A. Rapid-onset, linezolid-induced lactic acidosis in MELAS. Mitochondrion 2011; 11: 992-3. (21 year old man with mitochondrial encephalomyopathy, lactic acidosis and stroke-like episode syndrome [MELAS] developed tachypnea and rising lactate levels within a day of starting linezolid, rapidly returning to baseline upon stopping). 21907311
Su E, Crowley K, Carcillo JA, Michaels MG. Linezolid and lactic acidosis: a role for lactate monitoring with long-term linezolid use in children. Pediatr Infect Dis J 2011; 30: 804-6. (Three children [0.5, 0.5 and 16 years old], two boys and one girl, with hepatic and/or intestinal insufficiency developed lactic acidosis during extended therapy [53, 31 and 7 days] with oral linezolid, resolving rapidly upon stopping in two, but with progressive acidosis and death in 1 child). 21852764
Contou D, Fichet J, Grimaldi D, Cariou A. Early life-threatening lactic acidosis following a single infusion of linezolid. Int J Antimicrob Agents 2011; 38: 84-5. (81 year old man with chronic hepatitis C on ventilatory support for pneumonia with Enterococcus fecalis superinfection developed lactic acidosis within hours of starting intravenous linezolid [pH 7.03, lactate 16 mmol/L], resolving within hours of stopping). 21482079
Leach KL, Brickner SJ, Noe MC, Miller PF. Linezolid, the first oxazolidinone antibacterial agent. Ann N Y Acad Sci 2011 Mar; 1222: 49-54. (Overview from the sponsor of the discovery, development, mechanism of action, pharmacology, and spectrum of activity of linezolid, the first of a new class of antibiotics). 21434942
Miyawaki A, Ueda T, Nakao A, Adachi M, Ohya M, Yamada I, Takesue Y, et al. Linezolid-induced lactic acidosis followed by severe hypophosphatemia after discontinuation of linezolid. Surg Infect (Larchmt) 2013; 14: 229-30. (75 year old man developed lactic acidosis 72 days after starting oral linezolid [pH 7.09, lactate >25 mmol/L], developing severe hypophosphatemia, but ultimately recovering completely; no mention of liver injury). 23464676
Holmaas G, Lærum JH, Schjøtt J, Leiva RA. A man in his seventies with a long-term infection and severe acid-base imbalance. Tidsskr Nor Laegeforen 2014; 134: 315-319. (70 year old man developed lactic acidosis while on long term linezolid [bilirubin not given, ALT 1080 U/L, Alk P normal, INR >7.5, pH 7.03, lactate 27 mmol/L], with prompt improvement on stopping drug). 24518482
Prokocimer P, De Anda C, Fang E, Mehra P, Das A. Tedizolid phosphate vs linezolid for treatment of acute bacterial skin and skin structure infections: the ESTABLISH-1 randomized trial. JAMA 2013; 309: 559-69. (Among 667 adults with acute bacterial skin or skin-structure infections treated with tedizolid [200 mg daily for 6 days] vs linezolid [600 mg twice daily for 10 days], response rates were similar as were adverse events, ALT elevations above twice normal occurred in 4.1% vs 3.5%). 23403680
Das D, Tulkens PM, Mehra P, Fang E, Prokocimer P. Tedizolid phosphate for the management of acute bacterial skin and skin structure infections: safety summary. Clin Infect Dis 2014; 58 Suppl 1 S51-7. (Review of the safety of tedizolid as short term therapy of acute bacterial skin or skin-structure infectious summarizing results from Prokocimer [2013] and Moran [2014]). 24343833
Kisgen JJ, Mansour H, Unger NR, Childs LM. Tedizolid: a new oxazolidinone antimicrobial. Am J Health Syst Pharm 2014; 71: 621-33. (Review of the mechanism of action, pharmacokinetics, efficacy and safety of tedizolid; no mention of ALT elevations or hepatotoxicity). 24688035
Moran GJ, Fang E, Corey GR, Das AF, De Anda C, Prokocimer P. Tedizolid for 6 days versus linezolid for 10 days for acute bacterial skin and skin-structure infections (ESTABLISH-2): a randomised, double-blind, phase 3, non-inferiority trial. Lancet Infect Dis 2014; 14: 696-705. (Among 666 patients with acute bacterial skin or skin-structure infections treated with tedizolid [200 mg intravenous once daily for 6 days] or linezolid [600 mg twice daily by mouth for 10 days], response rates were similar while gastrointestinal side effects were less with tedizolid; no mention of ALT elevations or hepatotoxicity). 24909499
Two new drugs for skin and skin structure infections. Med Lett Drugs Ther 2014; 56 (1449): 73-5. (Concise review of mechanism of action, efficacy, safety and costs of tedizolid shortly after its approval in the US mentions that common side effects include nausea, headache, diarrhea, vomiting and dizziness, and potentially severe effects include optic and peripheral neuropathy, similar to linezolid). 25118799
Zhanel GG, Love R, Adam H, Golden A, Zelenitsky S, Schweizer F, Gorityala B, et al. Tedizolid: a novel oxazolidinone with potent activity against multidrug-resistant gram-positive pathogens. Drugs 2015; 75: 253-70. (Review of the structure, mechanism of action, antibacterial spectrum, bacterial resistance, efficacy and safety of tedizolid mentions a study of tedizolid in healthy controls of ascending doses given for 21 days in which one subject developed ALT elevations of more than twice normal after 11 days, that resolved rapidly upon stopping). 25673021
Flanagan S, Minassian SL, Morris D, Ponnuraj R, Marbury TC, Alcorn HW, Fang E, Prokocimer P. Pharmacokinetics of tedizolid in subjects with renal or hepatic impairment. Antimicrob Agents Chemother 2014; 58: 6471-6. (Analysis of the pharmacokinetics of single doses of tedizolid in patients with mild and moderate hepatic dysfunction found minimally altered plasma levels, the total area under the curve being increased by 22-34%). 25136024

## OTHER REFERENCE LINKS

1. Recent References on Tedizolid: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tedizolid+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tedizolid: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tedizolid)